# Etravirine

## OVERVIEW

### Introduction

Etravirine is a nonnucleoside reverse transcriptase inhibitor used in combination with other agents in the therapy of human immunodeficiency virus (HIV) infection and the acquired immunodeficiency syndrome (AIDS). Etravirine has been associated with transient serum aminotransferase elevations and with hypersensitivity reactions that can be associated with liver injury including acute liver failure.

### Background

Etravirine (e" tra vir' een) is a “second generation” nonnucleoside reverse transcriptase inhibitor that acts by noncompetitive binding to the HIV reverse transcriptase and indirectly inactivating its catalytic site. Etravirine is similar to nevirapine and efavirenz in its mechanism of action, but shares minimal structural features. Etravirine has a higher barrier to development of resistance than nevirapine and efavirenz, at least in vitro. Etravirine was approved for use in the United States in 2007, and current indications are as therapy of HIV infection in combination with other agents in antiretroviral treatment-experienced adult patients. Etravirine is available in tablets of 25, 100 and 200 mg under the brand name Intelence. The recommended dosage in adults is 200 mg orally twice daily. Common side effects include fatigue, dizziness, headache and skin rashes. Less common but potentially serious side effects include peripheral neuropathy, lipodystrophy, immune reconstitution syndrome, and hypersensitivity reactions including erythema multiforme, Stevens Johnson syndrome and toxic epidermal necrolysis.

### Hepatotoxicity

Serum aminotransferase elevations occur in a high proportion of patients on etravirine therapy, but increases above 5 times the upper limit of normal occur in only 2% to 3% of patients; this rate may be higher in patients who have hepatitis C coinfection. In most studies, the rate of liver enzyme elevations was no different in etravirine treated than among in comparator arms. In large clinical trials as well as open access studies, there were no reported instances of clinically apparent liver injury attributed to etravirine.

Skin rashes occur in 10% to 20% of patients on etravirine usually during the first 2 to 6 weeks of therapy, and this rate is higher than with other antiretroviral regimens or comparator arms and is the major reason for discontinuation of etravirine because of adverse events. The skin rash during etravirine therapy can be accompanied by other signs of hypersensitivity including Stevens Johnson Syndrome and immunoallergic hepatitis. Clinically apparent hepatotoxicity is rare, but cases of hepatitis accompanying rash and signs of hypersensitivity have been reported to the sponsor, some of which have resulted in fatalities. The clinical features of these cases have not been described in detail. Most cases of hypersensitivity hepatitis due to nonnucleoside reverse transcriptase inhibitors arise during the first 6 weeks of therapy and are accompanied by immunoallergic manifestations such as rash, fever, lymphadenopathy and eosinophilia. Recovery is usually prompt after discontinuation, but progressive fatal instances of liver injury can occur.

Likelihood score: D (possible cause of clinically apparent liver injury).

### Mechanism of Injury

Etravirine is extensively metabolized in the liver via the P450 system (CYP 2C19, 3A4, and 2C9) and hepatotoxicity from etravirine is likely due to a hypersensitivity reaction to an immunogenic intermediate of its metabolism.

### Outcome and Management

The severity of the liver injury reported with etravirine has ranged from mild and transient enzyme elevations to clinically apparent liver injury and acute liver failure. Chronic hepatitis and vanishing bile duct syndrome have not been reported. If hypersensitivity hepatic injury does occur, rechallenge should be avoided. However, there is unlikely to be cross sensitivity to the hepatic injury between etravirine and other nonnucleoside reverse transcriptase inhibitors.

Drug Class: Antiviral Agents, Antiretroviral Agents

Other Drugs in the Subclass, Nonnucleoside Reverse Transcriptase Inhibitors: Delavirdine, Doravirine, Efavirenz, Nevirapine, Rilpivirine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Etravirine – Intelence®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=etravirine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Etravirine | 269055-15-4 | C20-H15-Br-N6-O | Etravirine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 20 February 2018

Núñez M. Hepatotoxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-518. (Review of hepatotoxicity of antiviral agents; etravirine is listed as having been linked to cases of hepatic failure and associated with ALT elevations in ~3% of patients).
Flexner C. Antiretroviral agents and treatment of HIV infection. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1623-1664. (Textbook of pharmacology and therapeutics).
http://aidsinfo.nih.gov/drugs/398/etravirine/0/patient. (Summary of clinical information on etravirine for the public).
Rivero A, Mira JA, Pineda JA. Liver toxicity induced by non-nucleoside reverse transcriptase inhibitors. J Antimicrob Chemother 2007; 59: 342-6. (Review of liver toxicity of nevirapine and efavirenz, ALT elevations above 5 times ULN were reported in 1-8% of efavirenz compared to 4-16% of nevirapine recipients; no mention of etravirine). 17255142
Lazzarin A, Campbell T, Clotet B, Johnson M, Katlama C, Moll A, Towner W, et al.; DUET-2 study group. Efficacy and safety of TMC125 (etravirine) in treatment-experienced HIV-1-infected patients in DUET-2: 24-week results from a randomised, double-blind, placebo-controlled trial. Lancet 2007; 370: 39-48. (Trial of etravirine vs placebo combined with an optimized antiretroviral regimen for 24 weeks in 591 treatment experienced patients with HIV infection; little difference found in frequency of adverse reactions except for rash [14% vs 9%]; ALT elevations above 5 times ULN occurred in 2% on etravirine and 1% on placebo; no mention of clinically apparent liver injury, hepatitis or death from liver disease). 17617271
Madruga JV, Cahn P, Grinsztejn B, Haubrich R, Lalezari J, Mills A, Pialoux G, et al.; DUET-1 study group. Efficacy and safety of TMC125 (etravirine) in treatment-experienced HIV-1-infected patients in DUET-1: 24-week results from a randomised, double-blind, placebo-controlled trial. Lancet 2007; 370: 29-38. (Trial of etravirine vs placebo combined with a stable antiretroviral regimen for 24 weeks in 612 patients with HIV infection; adverse events were comparable except for rash in 20% on etravirine vs 10% in controls; ALT increase above 5 times ULN in 3% of etravirine vs 2% of controls; no mention of clinically apparent liver injury, hepatitis or death from liver disease in list of adverse events). 17617270
Soriano V, Puoti M, Garcia-Gascó P, Rockstroh JK, Benhamou Y, Barreiro P, McGovern B. Antiretroviral drugs and liver injury. AIDS 2008; 22: 1-13. (Review of hepatotoxicity of antiretroviral drugs with recommendations on management, stopping therapy if symptoms arise, with overt jaundice [direct bilirubin], evidence of mitochondrial toxicity, ALT above 10 times ULN, ALT at lower levels if newly marketed agent; important to rule out other causes; problematic agents include didanosine, stavudine and zidovudine; nevirapine and efavirenz, full dose ritonavir and tipranavir). 18090386
No hepatotoxicity found for etravirine. AIDS Patient Care STDS 2008; 22 (12): 1022. (New report of results of controlled trials of etravirine vs placebo for 48 weeks in 1203 patients with HIV infection; there were no differences in rates of serum enzyme elevations between etravirine vs placebo therapy and most were attributable to underlying chronic HBV or HCV coinfection). 19097262
Hughes CA, Robinson L, Tseng A, MacArthur RD. New antiretroviral drugs: a review of the efficacy, safety, pharmacokinetics, and resistance profile of tipranavir, darunavir, etravirine, rilpivirine, maraviroc, and raltegravir. Expert Opin Pharmacother 2009; 10: 2445-66. (Review of the efficacy and safety of tipranavir, darunavir, etravirine, rilpivirine, maraviroc and raltegravir; the incidence and severity of adverse events were similar between etravirine and placebo groups except for rash [19% vs 11%], generally arising in the first few weeks and resolving even with continuing therapy, requiring discontinuation in 2%; no mention of hepatotoxicity). 19678794
Hammer SM, Eron JJ Jr, Reiss P, Schooley RT, Thompson MA, Walmsley S, Cahn P, et al.; International AIDS Society-USA. Antiretroviral treatment of adult HIV infection: 2008 recommendations of the International AIDS Society-USA panel. JAMA 2008; 300: 555-70. (Updated recommendations on use of antiviral therapy in adults with HIV infection, including use of recently approved agents raltegravir, maraviroc and etravirine). 18677028
Etravirine (Intelence) for HIV infection. Med Lett Drugs Ther 2008; 50 (1288): 47-8. (Concise review of the clinical efficacy and safety of etravirine published shortly after its approval in the US; mentions that rash is common and can be severe and serum aminotransferase elevations can occur). 18551091
Portilla J. [Safety and tolerability of etravirine]. Enferm Infecc Microbiol Clin 2009; 27 Suppl 2: 21-6. Spanish. (Review of tolerability of etravirine; skin rash occurs in 19% of patients, but severe skin rash in <1%; in clinical trials, ALT elevations were reported in 5% of etravirine treated patients, but similar rates were found with comparator regimens and acute liver failure was not reported). 20116624
Katlama C, Haubrich R, Lalezari J, Lazzarin A, Madruga JV, Molina JM, Schechter M, et al.; DUET-1, DUET-2 study groups. Efficacy and safety of etravirine in treatment-experienced, HIV-1 patients: pooled 48 week analysis of two randomized, controlled trials. AIDS 2009; 23: 2289-300. (Abstract only: Combined results of registration trials of etravirine for HIV treatment-experienced patients; rash occurred in 19% of etravirine treated vs 11% of controls). 19710593
Drugs for HIV infection. Treat Guidel Med Lett 2011; 9 (106): 29-40. (Concise summary of status of therapies for HIV infection states that etravirine is effective in combination with other agents in achieving virologic control in treatment-experienced patients with documented resistance to other agents; mentions that it can cause rash and increases in serum aminotransferase levels). 21617596
Vispo E, Fernández-Montero JV, Labarga P, Barreiro P, Soriano V. Low risk of liver toxicity using the most recently approved antiretroviral agents but still increased in HIV-hepatitis C virus coinfected patients. AIDS 2013; 27: 1187-8. (Among 1982 patients starting antiretroviral therapy between 2010-2011, liver enzyme elevations occurred in 9% overall [17% vs 6% in those with or without HCV coinfection], but were above 5 times ULN in only 0.4%; no patient developed jaundice and only 6 required change in agents; the lowest rates were with etravirine). 23739226
Casado JL. Liver toxicity in HIV-infected patients receiving novel second-generation nonnucleoside reverse transcriptase inhibitors etravirine and rilpivirine. AIDS Rev 2013; 15: 139-45. (Review of hepatotoxicity of etravirine and rilpivirine from controlled trials and expanded access studies during which 1.7% of 2578 patients on etravirine had ALT elevations above 5 times ULN [3.7% in those with HBV or HCV coinfection]; no mention of clinically apparent liver injury with jaundice). 24002197
Surgers L, Lacombe K. Hepatoxicity of new antiretrovirals: a systematic review. Clin Res Hepatol Gastroenterol 2013; 37: 126-33. (Review of literature on the hepatotoxicity of newer antiretroviral agents used to treat HIV infection mentions that etravirine therapy is accompanied by a low rate of transient serum enzyme elevations and has not been linked to cases of severe hepatotoxicity). 23522569
Casado JL, Bañón S, Rodriguez MA, Moreno A, Moreno S. Efficacy and pharmacokinetics of the combination of etravirine plus raltegravir as novel dual antiretroviral maintenance regimen in HIV-infected patients. Antiviral Res 2015; 113: 103-6. (Among 25 patients with HIV infection and previous exposure to multiple antiretroviral agents who were treated with raltegravir and etravirine for an average of 2 years, there were no virologic breakthroughs and no ALT elevations requiring dose modification or interruption). 25460844
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 [1.3%] cases were attributed to antiretroviral agents, but none to etravirine). 25754159
Casado JL, Mena A, Bañón S, Castro A, Quereda C, Moreno A, Pedreira J, Moreno S. Liver toxicity and risk of discontinuation in HIV/hepatitis C virus-coinfected patients receiving an etravirine-containing antiretroviral regimen: influence of liver fibrosis. HIV Med 2016; 17: 62-7. (Among 211 patients with HIV infection treated with an etravirine containing antiretroviral regimen and followed for a median of 1.8 years, only one had an ALT elevation above 5 times ULN [who had HCV coinfection] and there was no association between preexisting hepatic fibrosis [assessed by elastography] and any degree of ALT elevation during therapy). 26122981
Fabbri G, Mastrorosa I, Vergori A, Mazzotta V, Pinnetti C, Grisetti S, Zaccarelli M, et al. Reactivation of occult HBV infection in an HIV/HCV Co-infected patient successfully treated with sofosbuvir/ledipasvir: a case report and review of the literature. BMC Infect Dis 2017; 17: 182. (54 year old woman with HIV and HCV coinfection as well as anti-HBc and anti-HBs [without HBsAg] was treated for HIV with darunavir/r and etravirine [without nucleoside analogues] and with sofosbuvir and ledipasvir for HCV, and shortly thereafter developed acute HBV reactivation [bilirubin 7.1 mg/dL, ALT 435 U/L, HBV DNA 1 million IU/L, HBsAg and HBeAg positive], resolving with addition of entecavir but remaining HBsAg positive). 28249574
http://www.aidsinfo.nih.gov/guidelines (Current and regularly updated guidelines on therapy of HIV infection in adults, adolescents and children).

## OTHER REFERENCE LINKS

1. Recent References on Etravirine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Etravirine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Etravirine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Etravirine)